# Ganciclovir

## OVERVIEW

### Introduction

Ganciclovir is a nucleoside analogue and antiviral agent used in therapy of cytomegalovirus infections. Valganciclovir is the valyl ester prodrug of ganciclovir which can be given orally. When given intravenously, ganciclovir can cause mild, transient and asymptomatic elevations in serum aminotransferase levels, but neither ganciclovir nor valganciclovir have been associated with clinically apparent liver injury.

### Background

Ganciclovir (gan sye' kloe vir) is an acyclic guanosine nucleoside analogue structurally related to acyclovir which has antiviral activity against many herpes viruses, including herpes simplex 1 and 2, Epstein-Barr virus and varicella-zoster, but is used largely in the therapy of cytomegalovirus (CMV) infections. Ganciclovir is phosphorylated intracellularly by viral kinases and the resultant triphosphate competes with guanosine for incorporation into viral DNA, blocking viral DNA polymerase activity. Because of the requirement for activation by viral kinases, ganciclovir is not active in non-infected cells. Ganciclovir is not well absorbed orally and must be given parenterally to achieved adequate levels for maximal antiviral effect. Valganciclovir (val" gan sye' kloe vir) is the L-valyl ester prodrug of ganciclovir which is well absorbed orally and rapidly converted to ganciclovir by intracellular hydrolases. Ganciclovir and valganciclovir are indicated for therapy and prophylaxis of severe CMV infections. Ganciclovir was approved for use in the United States in 1994 and is available in a parenteral formulation in generic forms and under the brand name of Cytovene. The usual recommended regimen of therapy in adults for CMV retinitis or systemic infection is 5 mg/kg intravenously every 12 hours for 2 to 3 weeks, which can be followed by maintenance oral therapy using valganciclovir. Valganciclovir was approved for use in 2001 and is available in 450 mg tablets and as a powder for solution under the brand name of Valcyte. Valganciclovir is recommended in doses of 900 mg once or twice daily. Valganciclovir has replaced oral ganciclovir in therapy and prophylaxis of CMV infections. Side effects of ganciclovir and valganciclovir therapy include headache, dizziness, confusion, tremors, nausea, diarrhea, fever, renal dysfunction, bone marrow suppression and rash.

### Hepatotoxicity

Intravenous administration of ganciclovir is associated with transient mild-to-moderate elevations in serum ALT levels in 2% of patients. These episodes have usually been asymptomatic and self-limited. CMV infection itself can cause liver enzyme elevations and may account for some abnormalities found during therapy. There is little evidence that either ganciclovir or valganciclovir can cause clinically apparent liver injury. Ganciclovir also has activity against HBV and HBV DNA levels decrease on treatment and can rebound when therapy is stopped, leading to an acute flare of hepatitis B, which can be symptomatic and severe.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Ganciclovir is metabolized intracellularly in viral infected cells, hepatic metabolism is minimal, and it is excreted largely unchanged by the kidneys, perhaps accounting for the absence or rarity of hepatic injury. The flare of hepatitis B that occurs when ganciclovir is stopped is probably caused by an immune reaction to the rapid return of HBV replication after therapy.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Famciclovir, Foscarnet, Letermovir, Valacyclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ganciclovir – Generic, Cytovene®

Valganciclovir – Generic, Valcyte®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ganciclovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ganciclovir | 82410-32-0 | C9-H13-N5-O4 | Ganciclovir Chemical Structure
Valganciclovir | 175865-60-8 | C14-H22-N6-O5 | Valganciclovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 March 2018

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that ganciclovir has not caused "overt hepatic injury").
Núñez M. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents; ganciclovir and valganciclovir have been linked to serum enzyme elevations during therapy, and cases of clinically apparent liver injury have been reported to the sponsor).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Review of liver toxicity of antiviral agents; intravenous administration of ganciclovir has been reported to cause serum aminotransferase elevations in 2% of patients). 8749901
Herraiz M, Beraza N, Solano A, Snagro B, Montoya J, Qian C, Prieto J, et al. Liver failure caused by herpes simplex virus thymidine kinase plus ganciclovir therapy is associated with mitochondrial dysfunction and mitochondrial DNA depletion. Human Gene Ther 2003; 14: 463-72. (In a rat model, the adenoviral transfer of thymidine kinase followed by ganciclovir leads to acute hepatocellular injury with evidence of mitochondrial injury, lactic acid elevations and morphologic changes; this form of toxicity is only a concern for gene therapy studies in which there may be gene transfer of the viral kinase to normal hepatocytes). 12691611
Reusser P. Oral valganciclovir: a new option for treatment of cytomegalovirus infection and disease in immunocompromised hosts. Expert Opin Investig Drugs 2001; 10: 1745-53. (Review of valganciclovir, an oral prodrug of ganciclovir, which is active against CMV infection and disease; no mention of hepatotoxicity or ALT elevations with therapy). 11772283
Shea BF, Hoffman S, Sesin GP, Hammer SM. Ganciclovir hepatotoxicity. Pharmacotherapy 1987; 7: 223-6. (33 year old man with HIV infection, CMV retinitis and mycobacterium avium intracellulare [MAC] infections developed increases in preexisting elevated enzyme levels without bilirubin elevations during two courses of ganciclovir [ALT 133 rising to ~500 U/L, AlkP 181 rising to 1014 U/L], peaking several weeks after stopping and then decreasing; liver biopsy showed MAC and no evidence of hepatitis). 2832836
Hochster H, Dieterich D, Bozzette S, Reichman RC, Connor JD, Liebes L, Sonke RL, et al. Toxicity of combined ganciclovir and zidovudine for cytomegalovirus disease associated with AIDS. An AIDS Clinical Trials Group Study. Ann Intern Med 1990; 113: 111-7. (40 patients with HIV and CMV infection were treated with zidovudine and intravenous ganciclovir; anemia and neutropenia were common; 1 patient developed hepatitis thought to be zidovudine-related, resolving on stopping and recurred on restarting zidovudine [timing and details not given]). 2163228
Figge HL, Bailie GR, Briceland LL, Kowalsky SF. Possible ganciclovir-induced hepatotoxicity in patients with AIDS. Clin Pharm 1992; 11: 432-4. (Retrospective review of 14 courses of ganciclovir in 11 patients with HIV infection identified 5 with associated elevations in AST [29-36 rising to 55-110 U/L] or Alk P [61 rising to 360 U/L], but all were receiving other potentially hepatotoxic agents and no patient was reported to develop hepatitis or jaundice). 1316254
Gish RG, Lau JY, Brooks L, Fang WS, Steady SL, Imperial JC, Garcia-Kennedy R, et al. Ganciclovir treatment of hepatitis B virus infection in liver transplant recipients. Hepatology 1996; 23: 1-7. (9 patients with recurrent hepatitis B after liver transplant were treated with ganciclovir for 3-10 months; serum HBV DNA and ALT levels decreased on therapy and flare occurred in 3 when ganciclovir was stopped, one becoming jaundiced and developing hepatic decompensation). 8550028
Noormohamed SE. Potential of ganciclovir to induce hepatotoxicity in patients with HIV disease. J Infect Dis Pharmacother 1997; 2: 95-101. Not in PubMed.
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; 8 were attributed to antiviral agents including one attibuted to valacyclovir, but none were attributed to ganciclovir or valganciclovir). 18955056
Witzke O, Hauser IA, Bartels M, Wolf G, Wolters H, Nitschke M; VIPP Study Group. Valganciclovir prophylaxis versus preemptive therapy in cytomegalovirus-positive renal allograft recipients: 1-year results of a randomized clinical trial. Transplantation 2012; 93: 61-8. (Controlled trial of prophylaxis vs preemptive therapy of CMV infection in 296 renal allograft recipients; overall tolerability was good and no mention of ALT elevations or hepatotoxicity). 22094954
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of safety and efficacy of ganciclovir and valganciclovir treatment and prophylaxis against CMV infection; mentions that adverse effects include "abnormal liver function"). 23459414
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two cases were attributed to valacyclovir and one to acyclovir, but none to ganciclovir or valganciclovir). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Ganciclovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ganciclovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ganciclovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ganciclovir)